# Plicamycin

## OVERVIEW

### Introduction

Plicamycin, which was formerly known as mithramycin, is an antibiotic that is used as an anticancer agent in the therapy of testicular and germ cell cancers. Plicamycin causes acute hepatic injury that arises within days of starting therapy, but is usually transient and asymptomatic and rarely leads to jaundice. Plicamycin has not been approved for use as cancer chemotherapy in the United States, but continues to be used on an investigational basis.

### Background

Plicamycin (plye” ka mye’ sin), which was formerly known as mithramycin, is an antineoplastic antibiotic that was first isolated from fermentation extracts of Streptomyces plicatus. It acts by binding to helical double-stranded DNA and blocking RNA synthesis. It has potent antitumor effects in vitro and has been evaluated in several solid tumors in humans. Because of its toxicities (including hepatotoxicities), it has not been approved for use in the United States. Nevertheless, plicamycin has distinctive and sometimes potent activities against germ cell and testicular cancers and continues to be investigated as an experimental therapy in patients with advanced and resistant forms of cancer. Plicamycin is also effective in reducing hypercalcemia associated with malignancy, probably by inhibition of osteoblast function, but its use has been replaced by less toxic approaches such as corticosteroids and bisphosphonates. For the treatment of cancer, plicamycin is administered intravenously in doses of 25 to 50 μg/kg daily for 5 to10 days in 2 to 6 monthly courses. Side effects of plicamycin are common and often dose limiting, including bone marrow suppression, irritability, agitation, gastrointestinal upset, diarrhea, nausea, anorexia, weakness, fever, rash, epistaxis, bruising and hemorrhage.

### Hepatotoxicity

Chemotherapy with plicamycin causes serum enzyme elevations in almost all patients who are treated for more than 1 or 2 days and who are monitored during therapy. Serum ALT, AST and LDH values begin to rise within 3 days of the first infusion and peak within 7 to 10 days at levels of 5 to 500 times the upper limit of the normal range (ULN). The elevations, however, are transient and resolve within 1 to 3 weeks and are rarely associated with symptoms or jaundice. Liver biopsies taken during these episodes usually demonstrate centrolobular necrosis and congestion. With repeated courses, elevations continue to occur generally to the same or lesser degree. A single instance of acute liver failure arising within days of therapy that was suggestive of ischemic hepatitis or sinusoidal obstruction syndrome has been reported in a patient treated with full doses of plicamycin for 4 days for nonmalignant hypercalcemia. Otherwise, the serum enzyme elevations, despite being moderate to severe, are transient and benign.

Likelihood score: A[HD] (well known cause of clinically apparent liver injury with high dose intravenous treatment).

### Mechanism of Injury

Plicamycin appears to be a direct, intrinsic hepatotoxin as the injury can be produced in animal models and occurs in almost all patients. The injury is likely to be dose related and is not more severe or more rapid in onset with rechallenge. Experimental studies suggest that the hepatotoxicity of plicamycin relates to inhibition of farnesoid X receptor signaling leading to deregulation of bile acid homeostasis.

### Outcome and Management

The hepatic injury caused by plicamycin is usually reversible and requires no intervention. The hepatotoxicity of plicamycin has limited its usefulness, and it is considered contraindicated in patients with significant underlying liver disease.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Antibiotics, Cytotoxic: Bleomycin, Dactinomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitomycin, Mitoxantrone

## CASE REPORT

### Case 1. Marked serum aminotransferase elevations during intravenous therapy with plicamycin.(1)

A 63 year old man with intrathoracic mesothelioma participating in a phase II clinical trial at the Clinical Center of the National Institutes of Health was started on intravenous plicamycin (25 mcg/kg/day) and developed marked serum aminotransferase elevations within 2 days. He had no history of liver disease, alcohol abuse or known drug allergies and was known to have normal liver tests before starting treatment. He had no symptoms of liver injury and was not receiving other medications. ALT levels peaked at 4832 U/L and AST levels at 4889 U/L a day after stopping therapy and then fell promptly (Table). Tests for hepatitis A, B and C were negative as were routine autoantibodies. Ultrasound of the liver suggested heterogeneity of the liver texture, but showed no other abnormalities, liver masses or evidence of obstruction. A liver biopsy showed centrolobular (zone 3) necrosis and hemorrhage with mild inflammation and no fibrosis or steatosis. After his serum enzymes returned to normal, he was rechallenged with a lower dose of plicamycin (18 mcg/kg/day) and serum aminotransferase levels again rose within a few days, but to a lesser degree (peak ALT 454 U/L). No further therapy with plicamycin was given.

#### Key Points

Medication: | Plicamycin
Pattern: | Hepatocellular (R=193)
Severity: | 1+ (never jaundiced)
Latency: | 3 days
Recovery: | Complete recovery within 4 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
Pre | Pre | 32 | 85 | 0.3 | Plicamycin started, INR 0.94
1 day | Pre | 37 | 68 | 0.6 | INR 0.89
2 days | Pre | 48 | 73 | 0.3
3 days | 0 | 714 | 75 | 0.3 | Ultrasound
4 days | 1 day | 4832 | 71 | 0.6 | LDH 5995 U/L, liver biopsy
5 days | 2 days | 3510 | 72 | 0.9 | INR 1.23
6 days | 3 days | 2144 | 155 | 0.9
7 days | 4 days | 1522 | 193 | 0.7
1 month | 26 days | 37 | 80 | 0.6 | Plicamycin restarted
[3 days] | | 142 | 86 | 0.2 | INR 0.99
[5 days] | | 454 | 126 | 0.4
Normal Values | | <42 | <115 | <1.2

#### Comment

The serial test results demonstrated the typical pattern of serum enzyme elevations with plicamycin therapy. The pattern is that of acute hepatic necrosis and is self-limited if therapy is stopped promptly. In this clinical trial, 10 of 12 treated patients developed hepatotoxicity with a pattern similar to the one shown. No patient developed jaundice, and symptoms, when present, were mild and nonspecific (mild nausea and abdominal discomfort).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Plicamycin – Generic, Mithracin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Plicamycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Plicamycin | 18378-89-7 | C52-H76-O24

## CITED REFERENCE

1 Sissung TM, Huang PA, Hauke RJ, McCrea EM, Peer CJ, Barbier RH, Strope JD, et al. (2019). Severe hepatotoxicity of mithramycin therapy caused by altered expression of hepatocellular bile transporters. Mol Pharmacol.

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2020

Zimmerman HJ. Antibiotics. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 694-8. (Expert review of hepatotoxicity published in 1999 mentions that mithramycin [plicamycin] is "highly toxic" and that hepatic injury occurs in 25-100% of patients, and is marked by very high elevations in ALT levels).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that mithramycin hepatotoxicity is uncommon with dosing used for hypercalcemia, but frequent with daily dosing used in cancer).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-203. (Textbook of pharmacology and therapeutics).
Kofman S, Medrek TJ, Alexancer RW. (1964). Mithramycin in the treatment of embryonal cancer. Cancer. (Retrospective analysis of 26 patients with embryonic cell cancers treated with plicamycin found dramatic responses in a few patients, but therapy was limited by toxicities, largely to the bone marrow, no mention of hepatotoxicity).
Brown JH, Kennedy BJ. (1965). Mithramycin in the treatment of disseminated testicular neoplasms. N Engl J Med. (Among 12 patients with testicular cancer treated with 2 to 6 courses of plicamycin, 7 had objective regression, all had hepatotoxicity with ALT rising after 3-5 days to as high as 21,000 U/L, then resolving with no jaundice and no deaths from liver disease).
Morrison RK, Brown DE, Oleson JJ. (1967). A toxicologic study of mithramycin. Toxicol Appl Pharmacol. (In monkeys and dogs, doses of plicamycin of 0.1 mcg/kg caused marked serum ALT elevations within 5-7 days).
Ream NW, Perlia CP, Wolter J, Taylor SG. (1968). Mithramycin therapy in disseminated germinal testicular cancer. JAMA. (Among 30 patients with disseminated testicular cancer treated with plicamycin, 9 had an objective response, ALT elevations occurred with each course but returned to normal within 2-3 weeks and no patient developed jaundice; autopsy in 1 patient showed "toxic fatty metamorphosis").
Ansfield FJ. (1969). Clinical studies with mithramycin. Oncology. (Among 46 patients with various solid tumors treated with plicamycin [78 courses] in varying doses, moderate-to-severe toxicity occurred in all and 4 patients died; 11 of 22 patients who were monitored had ALT elevations, but all reversed within 1 month).
Ryan WG, Schwartz TB, Northrop G. (1970). Experiences in the treatment of Paget's disease of bone with mithramycin. JAMA. (Among 15 patients with Paget disease of bone treated with plicamycin, serum enzyme elevations occurred, the most sensitive enzyme being isocitric dehydrogenase [ICD], which rose up to 160 times ULN).
Kennedy BJ. (1970). Metabolic and toxic effects of mithramycin during tumor therapy. Am J Med. (Among 58 patients with advanced cancers treated with plicamycin, side effects were common including malaise, gastrointestinal upset, fever, headache, irritability, agitation, rash, stomatitis, epistaxis and hemorrhage; ALT or AST elevations occurred in all [up to 8,000 U/L], usually resolving rapidly).
Kennedy BJ. (1970). Mithramycin therapy in advanced testicular neoplasms. Cancer. (Among 44 patients with advanced testicular cancer treated with plicamycin, alternate day regimens were more effective and less toxic than standard daily regimens of administration, but all patients had transient LDH elevations during therapy).
Foley JF, Lemon HM, Miller DM, Kessinger A. (1972). The treatment of metastatic testicular tumors. J Urol. (Among 11 patients with testicular cancer treated with plicamycin and 7 with dactinomycin, all developed transient serum enzyme elevations).
Ellas EG, Reynoso G, Mittelman A. (1972). Control of hypercalcemia with mithramycin. Ann Surg. (Among 12 patients with hypercalcemia treated with plicamycin [25 mcg/kg for 1 to 5 days], calcium levels fell in all, AST values rose [77-1250 U/L] in those treated for 3-5 days, but not in those given 1-2 doses only).
Ryan WG. (1973). Mithramycin in Paget's disease of bone. Lancet. (Among 97 patients with Paget disease treated with plicamycin, all had increases in serum enzymes, but the abnormalities resolved promptly, and no patient had evidence of residual liver damage).
Fraisse F, Marche C, Gibert C, Coquin Y, Vachon F. (1980). Ann Med Interne (Paris). (26 year old woman treated with plicamycin for nonmalignant hypercalcemia for 4 days [total dose of 5 mg] developed marked increase in ALT [1,600 U/L], coagulopathy, thrombocytopenia, hemorrhage and shock, dying within days of multiorgan failure).
Green L, Donehower RC. (1984). Hepatic toxicity of low doses of mithramycin in hypercalcemia. Cancer Treat Rep. (Among 67 patients with malignant hypercalcemia treated with plicamycin, AST elevations occurred in all, starting within 2 days and resolving within 2-3 weeks; no patient was jaundiced and repeat courses caused similar reactions which were not more severe).
Hémon Y, Martin C, Auffray JP, Bonneru JJ, Brunet C, Farisse J. (1985). Ann Fr Anesth Reanim. (64 year old woman with hypercalcemia developed acute liver failure two days after an infusion of mithramycin and one day after parathyroid surgery).
Sznol M, Ohnuma T, Holland JF. (1987). Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis. (Overview of hepatotoxicity of antineoplastic agents, mentions that mithramycin displays dose related hepatotoxicity in animals and in humans marked by aminotransferase and lactic dehydrogenase elevations).
Davidson TG. (2001). Conventional treatment of hypercalcemia of malignancy. Am J Health Syst Pharm. (Review of therapy of malignant hypercalcemia mentions that plicamycin can be effective, but has a variable and unpredictable duration of response and is usually reserved for cases in which other therapies have failed).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to mithramycin).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab, but none to mithramycin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, ten were attributed to antineoplastic agents, but none to plicamycin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, but none to plicamycin).
Sissung TM, Huang PA, Hauke RJ, McCrea EM, Peer CJ, Barbier RH, Strope JD, et al. (2019). Severe hepatotoxicity of mithramycin therapy caused by altered expression of hepatocellular bile transporters. Mol Pharmacol. (12 patients with various malignancies were treated with 20 cycles of intravenous plicamycin of whom 10 developed ALT elevations that were above 5 times ULN in 8; molecular analyses suggested that the plicamycin hepatotoxicity was mediated by inhibition of FXR signaling: Case 1).

## OTHER REFERENCE LINKS

1 Recent References on Plicamycin: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Plicamycin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Plicamycin: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=Plicamycin)